# Leuprolide

## OVERVIEW

### Introduction

Leuprolide is a parenterally administered, gonadotropin releasing hormone (GnRH) agonist which causes an inhibition of estrogen and androgen production and is used predominantly to treat advanced prostate cancer. Leuprolide has been associated with a modest rate of serum enzyme elevations during therapy, but has not been convincingly linked to instances of clinically apparent acute liver injury.

### Background

Leuprolide (loo' proe lide), also called leuprorelin (loo" proe rel' in), is a nonapeptide analogue of gonadotropin releasing hormone (GnRH) that acts as a partial agonist of the gonadotropin receptors in the pituitary that induce secretion of luteinizing hormone (LH) and follicle stimulating hormone (FSH). These gonadotropins cause production and secretion of testosterone by the male testes and estrogen by the female ovaries. The continued receptor occupancy by leuprolide, however, ultimately causes a down-regulation of production of LH and FSH and a resultant decrease in testosterone and estrogen levels. Leuprolide, alone or in combination with other antiandrogens, has been found to be palliative in advanced prostate cancer. Leuprolide was approved for use in the United States in 1989 and is still widely used, being considered a first line therapy in management of prostate cancer, the GnRH agonists having largely replaced surgical castration in the medical management of prostate cancer. Leuprolide is also used off label for hormonally sensitive benign conditions such as endometriosis, uterine fibroids, precocious puberty, infertility, and gender affirming therapy. Leuprolide is available generically and under the brand name Lupron in solution for daily subcutaneous injections (1 mg) or in long acting depot forms which are administered intramuscularly every 1 (7.5 mg), 3 (22.5 mg), 4 (30 mg) or 6 (45 mg) months. Leuprolide and the other GnRH analogues cause a profound hypogonadism ("chemical castration") and its common side effects are typical of androgen deprivation, including hot flashes, loss of libido, erectile dysfunction, depression, nausea, diarrhea, weight gain and fluid retention. Rare, but potentially severe adverse events include immediate hypersensitivity reactions, pituitary apoplexy and, with long term use, weight gain, metabolic changes, diabetes and osteoporosis.

### Hepatotoxicity

Leuprolide has been associated with mild serum enzyme elevations during therapy in 3% to 5% of patients, but values above 3 times the upper limit of normal are rare, being reported in less than 1% of recipients. The serum enzyme elevations during leuprolide therapy have generally been transient and asymptomatic, resolving even with drug continuation and rarely requiring dose modification or discontinuation. Despite use for several decades, leuprolide has not been linked to convincing cases of clinically apparent liver injury. Routine monitoring of patients for liver test abnormalities is not recommended.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver test abnormalities during leuprolide therapy is not known. Leuprolide is a short polypeptide and is metabolized locally in many tissues. It is not metabolized by the hepatic cytochrome P450 system and has not been associated with significant drug-drug interactions. Some serum enzyme elevations may be caused by nonalcoholic fatty liver, arising because of weight gain or metabolic changes caused by the androgen deprivation state induced by the GnRH agonist.

### Outcome and Management

The serum enzyme elevations that occur on leuprolide therapy usually do not require dose adjustment or drug discontinuation, but should lead to a search for other causes of liver disease. There is no evidence to indicate that there is cross sensitivity to liver injury among the various GnRH analogues.

Drug Class: Antineoplastic Agents, GnRH Analogues

Other Drugs in the Subclass, GnRH Analogues: Degarelix, Goserelin, Histrelin, Relugolix, Triptorelin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Leuprolide – Generic, Lupron®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Leuprolide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Leuprolide | 53714-56-0 | C59-H84-N16-O12

## ANNOTATED BIBLIOGRAPHY

References updated: 28 May 2023

Abbreviations: FSH, follicle stimulating hormone; GnRH, gonadotropin releasing hormone; LH, luteinizing hormone; PSA, prostate specific antigen.

Zimmerman HJ Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 699. (Expert review of hepatotoxicity published in 1999; leuprolide is not discussed).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of hormonal products; does not discuss the GnRH agonists such as leuprolide).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-48. (Textbook of pharmacology and therapeutics).
Levin ER, Vitek WS, Hammes SR. Estrogens, progestins, and the female reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 803-31. (Textbook of pharmacology and therapeutics).
Snyder PJ. Androgens and the male reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 833-43. (Textbook of pharmacology and therapeutics).
Leuprolide Study Group. (1984). Leuprolide versus diethylstilbestrol for metastatic prostate cancer. N Engl J Med. (Among 177 patients with advanced prostate cancer treated with leuprolide or DES, objective response rates were similar with both agents, but side effects were less with leuprolide; no mention of ALT elevations or hepatotoxicity).
Dlugi AM, Miller JD, Knittle J. (1990). Lupron depot (leuprolide acetate for depot suspension) in the treatment of endometriosis: a randomized, placebo-controlled, double-blind study. Lupron Study Group. Fertil Steril. (Among 52 women with endometriosis treated with monthly injections of leuprolide or placebo for 6 months, there were minor changes in mean AST [18 to 22 U/L] and Alk P [62 to 79 U/L] levels in leuprolide treated patients, but these were not considered clinically important).
Eri LM, Tveter KJ. (1994). Safety, side effects and patient acceptance of the luteinizing hormone releasing hormone agonist leuprolide in treatment of benign prostatic hyperplasia. J Urol. (Among 50 men with benign prostatic hyperplasia treated with leuprolide or placebo injections monthly for 6 months, side effects were frequent, and tolerance was poor with leuprolide including hot flashes, erectile dysfunction, weight gain and fatigue; no mention of ALT elevations or hepatotoxicity).
Maillefert JF, Sibilia J, Kuntz JL, Tavernier C. (1994). Gonadotrophin-releasing hormone agonists induce osteoporosis. Br J Rheumatol. (Two men with prostate cancer, ages 58 and 69 years, were treated with leuprolide for 3 years and triptorelin for 9 months when they presented with back pain and vertebral fractures, which were not present on pretreatment imaging).
Kienle E, Lübben G. (1996). Efficacy and safety of leuprorelin acetate depot for prostate cancer. The German Leuprorelin Study Group. Urol Int. (Among 205 men with prostate cancer treated with monthly subcutaneous depot leuprolide, the major side effect was hot flashes: no mention of ALT elevations or hepatotoxicity).
Fowler JE, Gottesman JE, Reid CF, Andriole GL, Soloway MS. (2000). Safety and efficacy of an implantable leuprolide delivery system in patients with advanced prostate cancer. J Urol. (Among 27 patients who received one and 24 who receive two leuprolide implants with controlled drug delivery, testosterone suppression was maintained for a year and adverse events included hot flashes [75%], depression [10%], impotence [6%] and fatigue [8%]; no mention of ALT elevations or hepatotoxicity).
Hands KE, Alvarez A, Bruder JM. (2007). Gonadotropin-releasing hormone agonist-induced pituitary apoplexy in treatment of prostate cancer: case report and review of literature. Endocr Pract. (Review of 7 cases of pituitary apoplexy occurring after initiation of GnRH agonist therapy for prostate cancer).
Klotz L, Boccon-Gibod L, Shore ND, Andreou C, Persson BE, Cantor P, Jensen JK, et al. (2008). The efficacy and safety of degarelix: a 12-month, comparative, randomized, open-label, parallel-group phase III study in patients with prostate cancer. BJU Int. (Among 610 patients with advanced prostate cancer treated with degarelix or leuprolide, common adverse events included injection site reactions [40% vs <1%], hot flashes [26% vs 21%], weight gain [10% vs 12%] and ALT elevations [9% vs 5%]; one patient on degarelix stopped therapy because of liver test abnormalities, but there were no instances of clinically apparent liver injury or liver injury with jaundice).
Guerra Y, Lacuesta E, Marquez F, Raksin PB, Utset M, Fogelfeld L. (2010). Apoplexy in nonfunctioning pituitary adenoma after one dose of leuprolide as treatment for prostate cancer. Pituitary. (60 year old man with prostate cancer developed headaches and neurologic symptoms within 24 hours of a first injection of leuprolide, and subsequent evaluation revealed a previously unsuspected nonfunctioning pituitary adenoma).
Marberger M, Kaisary AV, Shore ND, Karlin GS, Savulsky C, Mis R, Leuratti C, Germa JR. (2010). Effectiveness, pharmacokinetics, and safety of a new sustained-release leuprolide acetate 3.75-mg depot formulation for testosterone suppression in patients with prostate cancer: a Phase III, open-label, international multicenter study. Clin Ther. (Among 160 men with advanced prostate cancer treated with leuprolide [3.75 mg by subcutaneous depot injection] monthly for 6 months, the major side effects were hot flashes [45%] and injection site reactions [18%]; "All changes from baseline or shifts in routine laboratory values...were judged not clinically significant").
Crawford ED, Phillips JM. (2011). Six-month gonadotropin releasing hormone (GnRH) agonist depots provide efficacy, safety, convenience, and comfort. Cancer Manag Res. (Review of results on two GnRH agonist depot formulations for advanced prostate cancer that allow for every 6-month administration [leuprolide and triptorelin], both provide sustained testosterone suppression and have adverse side effects similar to other GnRH agonist formulations; mentions a single episode of ALT and AST elevation in a patient receiving triptorelin).
Lee PA, Klein K, Mauras N, Neely EK, Bloch CA, Larsen L, Mattia-Goldberg C, Chwalisz K. (2012). Efficacy and safety of leuprolide acetate 3-month depot 11.25 milligrams or 30 milligrams for the treatment of central precocious puberty. J Clin Endocrinol Metab. (Among 84 children with precocious puberty treated with leuprolide 3-month depot injections [11.25 versus 30 mg], hormonal suppression was better with the higher dose and adverse events were similar, including injection site pain [23%], headache [20%] and weight gain [8%]; no mention of ALT elevations or hepatotoxicity).
Van Poppel H, Klotz L. (2012). Gonadotropin-releasing hormone: an update review of the antagonists versus agonists. Int J Urol. (Review of androgen deprivation therapy for prostate cancer using GnRH agonists and antagonists stressing the more rapid onset of action and similar if not better safety profile of GnRH antagonists).
Walker LM, Tran S, Robinson JW. (2013). Luteinizing hormone--releasing hormone agonists: a quick reference for prevalence rates of potential adverse effects. Clin Genitourin Cancer. (Systematic review of adverse event profile of long term use of GnRH agonists which mostly relate to the hormonal changes that occur such as hot flashes, gynecomastia, genital shrinkage, hair loss, osteoporosis, mild anemia, hyperglycemia, increased weight, loss of skeletal muscle mass, emotional lability, depression, loss of sexual desire and erectile dysfunction; no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to leuprolide or any of the GnRH analogues).
Braeckman J, Michielsen D. (2014). Efficacy and tolerability of 1- and 3-month leuprorelin acetate depot formulations (Eligard(®)/Depo-Eligard(®)) for advanced prostate cancer in daily practice: a Belgian prospective non-interventional study. Arch Med Sci. (Among 243 Belgian men with prostate cancer treated with either 1- or 3-month depot formulations of leuprolide, the most common adverse events were injection site pain [19%], hot flashes [9%] and transient tumor flares [5%]; no mention of ALT elevations or hepatotoxicity).
Lee PA, Klein K, Mauras N, Lev-Vaisler T, Bacher P. (2014). 36-month treatment experience of two doses of leuprolide acetate 3-month depot for children with central precocious puberty. J Clin Endocrinol Metab. (Among 72 children followed in 20 pediatric centers for precocious puberty who were treated with the 3-month depot formulations of leuprolide [11.25 or 30 mg] for up to 3 years, hormonal suppression was similar with the two doses as were adverse events, and "no new or unexpected safety concerns were identified based on laboratory testing").
Miller K, Simson G, Goble S, Persson BE. (2015). Efficacy of degarelix in prostate cancer patients following failure on luteinizing hormone-releasing hormone agonist treatment: results from an open-label, multicentre, uncontrolled, phase II trial(CS27). Ther Adv Urol. (Among 37 patients with advanced prostate cancer who had failed therapy with a GnRH agonist [including leuprolide], switching to degarelix for up to 1 year yielded a low rate of response [8%], with poor tolerance and a high dropout rate; changes in clinical chemistry results were "small, with no consistent trends").
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e.7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to leuprolide or any of the GnRH analogues).
Gava G, Cerpolini S, Martelli V, Battista G, Seracchioli R, Meriggiola MC. (2016). Cyproterone acetate vs leuprolide acetate in combination with transdermal oestradiol in transwomen: a comparison of safety and effectiveness. Clin Endocrinol (Oxf). (Among 40 trans-women treated with cyproterone or leuprolide combined with transdermal estrogens for 12 months, suppression of gonadotrophins was achieved in both groups and no major adverse events occurred; no mention of ALT elevations or hepatotoxicity).
Shiba E, Yamashita H, Kurebayashi J, Noguchi S, Iwase H, Ohashi Y, Sasai K, et al. (2016). A randomized controlled study evaluating safety and efficacy of leuprorelin acetate every-3-months depot for 2 versus 3 or more years with tamoxifen for 5 years as adjuvant treatment in premenopausal patients with endocrine-responsive breast cancer. Breast Cancer. (Among 222 premenopausal Japanese women with breast cancer treated with tamoxifen and adjuvant leuprorelin for 2 vs 3 or more years, estrogen levels remained suppressed with continued therapy and disease-free survival remained high, while adverse events were similar; 1 subject developed ALT elevations above 5 times ULN and rates of hepatic steatosis were 10% [2 years only] vs 14% [3 years or more]).
Kurebayashi J, Toyama T, Sumino S, Miyajima E, Fujimoto T. (2017). Efficacy and safety of leuprorelin acetate 6-month depot, TAP-144-SR (6M), in combination with tamoxifen in postoperative, premenopausal patients with hormone receptor-positive breast cancer: a phase III, randomized, open-label, parallel-group comparative study. Breast Cancer. (Among 167 premenopausal women with breast cancer treated with tamoxifen and leuprorelin [depot injections every 3 or 6 months], adverse events included hot flush [55%], injection site pain [30%], headache [24%] and back pain [12%] and one patient in each group discontinued therapy because of liver enzyme elevations).
Bolton EM, Lynch TH. (2018). Are all gonadotropin-releasing hormone agonists equivalent for the treatment of prostate cancer? A systematic review. BJU Int. (Systematic review of literature on relative efficacy and safety of different GnRH agonists, indicates that there is little evidence of superiority of any of the four, largely because of lack of adequately powered, controlled studies comparing them).
Cornford P, Jefferson K, Cole O, Gilbody J. (2018). Effects of initiating or switching to a six-monthly triptorelin formulation on prostate cancer patient-healthcare interactions and hospital resource use: a real-world, retrospective, non-interventional study. Oncol Ther. (Among 41 adults with advanced prostate cancer who were switched from every 1 or 3 monthly GnRH regimen to 6 monthly triptorelin, healthcare visits, injections and PSA testing were less as were adverse side effects including fatigue [12% vs 26%], urinary frequency [9% vs 32%], and bone pain [7% vs 14%]; no mention of ALT elevations or hepatotoxicity).
Shore ND, Saad F, Cookson MS, George DJ, Saltzstein DR, Tutrone R, Akaza H, et al., HERO Study Investigators. (2020). Oral relugolix for androgen-deprivation therapy in advanced prostate cancer. N Engl J Med. (Among 930 men with advanced prostate cancer treated with relugolix [120 mg daily by mouth] or leuprolide [by injection every 3 months] for 48 weeks, sustained suppression of testosterone to castration levels was achieved by 97% on relugolix vs 89% on leuprolide while common adverse event rates were similar with ALT elevations above 3 times ULN in 1.4% vs 1.3%, although major adverse cardiovascular events arose in 2.8% vs 5.6%).
Sawazaki H, Kitamura Y, Yagi K, Arai Y. (2020). Impact of androgen deprivation therapy on non-alcoholic fatty liver disease in patients with prostate cancer: a CT evaluation. Urol Int. (Among 77 patients with prostate cancer treated with androgen deprivation therapy [32 with leuprolide and 45 degarelix] for 6 months, computerized tomography demonstrated development of fatty liver in 7 patients but little change in body weight).
Wallach JD, Deng Y, McCoy RG, Dhruva SS, Herrin J, Berkowitz A, Polley EC, et al. (2021). Real-world cardiovascular outcomes associated with degarelix vs leuprolide for prostate cancer treatment. JAMA Netw Open. (Among 2226 men with advanced prostate cancer who initiated degarelix or leuprolide therapy between 2007 and 2019 who were propensity-matched for risk factors, major adverse cardiovascular event [MACE] rates were similar in the two groups [10.2 vs 8.6 per 100-patient years], although degarelix was associated with a high rate of death from any cause).
Lopes RD, Higano CS, Slovin SF, Nelson AJ, Bigelow R, Sørensen PS, Melloni C, et al., PRONOUNCE Study Investigators. (2021). Cardiovascular safety of degarelix versus leuprolide in patients with prostate cancer: the primary results of the PRONOUNCE randomized trial. Circulation. (Among 545 men with prostate cancer and concurrent atherosclerosis cardiovascular disease treated with degarelix or leuprolide for at least one year, major cardiovascular adverse events [MACE} arose in 5.5% vs 4.1% and rates of testosterone suppression, disease progression, discontinuations for adverse events and serious adverse event rates were similar in both groups).
Lambertini M, Boni L, Michelotti A, Magnolfi E, Cogoni AA, Mosconi AM, Giordano M, et al., GIM study group. (2022). Long-term outcomes with pharmacological ovarian suppression during chemotherapy in premenopausal early breast cancer patients. J Natl Cancer Inst. (Among 281 women with early onset breast cancer treated with chemotherapy with or without a GnRH analogue to preserve ovarian function, disease-free and overall survival were similar in the two groups and those given the GnRH analogue were slightly more likely to have a successful pregnancy during follow up [6.5% vs 3.2%]; no mention of other adverse events, ALT levels or hepatotoxicity).
Popovic J, Geffner ME, Rogol AD, Silverman LA, Kaplowitz PB, Mauras N, Zeitler P, et al. (2022). Gonadotropin-releasing hormone analog therapies for children with central precocious puberty in the United States. Front Pediatr. (Review of the 3 GnRH analogues used to treat children with precocious puberty including leuprolide, triptorelin, and histrelin which have different regimens of administration [intramuscular and subcutaneous] and durations of action [1-12 months]; no mention of liver adverse events).
Bahl A, Rajappa S, Rawal S, Bakshi G, Murthy V, Patil K. (2022). A review of clinical evidence to assess differences in efficacy and safety of luteinizing hormone-releasing hormone (LHRH) agonist (goserelin) and LHRH antagonist (degarelix). Indian J Cancer. (Systematic review of studies comparing the efficacy and safety of the 3 GnRH analogues used in therapy of prostate cancer identified 12 studies which showed overall no differences in efficacy in reducing serum testosterone levels and, in 4 studies reporting data on safety, similar degrees of tolerance and rates of adverse events: no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Leuprolide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Leuprolide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Leuprolide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Leuprolide)